# Vitamin A

## OVERVIEW

### Introduction

Vitamin A is a fat soluble vitamin necessary for health, deficiency of which can cause disorders of vision, skin, bone and immunity. The recommended daily allowance for vitamin A is 300 to 700 μg for children and approximately 700 to 900 μg for adults, amounts which can be provided by a normal diet. Higher doses of vitamin A can be toxic, leading to a constellation of signs and symptoms as well as liver injury, jaundice, enlargement of the liver and spleen, portal hypertension and cirrhosis.

### Background

Vitamin A is a retinoid and a fat-soluble vitamin that is commonly found in eggs, milk and liver and in the form of provitamin A in carotenoids in fresh fruits and vegetables particularly those with red, orange or yellow color. Highest levels of vitamin A are found in liver. The recommended daily allowance (RDA) for vitamin A is 700 to 900 μg/day (~2300 to 4300 IU) in adults and 300 to 700 μg/day (~1000 to 2000 IU) in children. Multiple generic forms of vitamin A are available as tablets, capsules, and solutions in over-the-counter preparations, alone and in combination with other vitamins and minerals, as well as a component in herbal mixtures, creams and ointments.

### Hepatotoxicity

Normal doses of vitamin A are not associated with liver injury or liver test abnormalities, but higher doses (generally more than 40,000 IU daily, ~12,000 μg) can be toxic. Acute toxicity is caused by a single or a few repeated very high doses (generally >100 times the RDA), arising within days to weeks with a typical symptom complex of severe headache, nausea, vertigo, blurred vision, muscle aches and lack of coordination, followed by skin desquamation and alopecia. Severe overdose can cause increased cerebral spinal fluid pressure, progressive drowsiness and coma. Chronic hypervitaminosis A usually arises 3 months to many years after starting moderately high levels of vitamin A (generally 10 times the RDA) and is marked by dry skin, cheilosis, gingivitis, muscle and joint pains, fatigue, mental dullness, depression and liver test abnormalities. Serum bilirubin is typically only mildly elevated. Serum aminotransferase and alkaline phosphatase levels are variably increased, but usually only 1 to 4 times the upper limit of normal. Serum vitamin A levels are typically, but not invariably elevated. Liver biopsy is diagnostic and shows enlarged, lipid-laden stellate cells with variable degrees of sinusoidal fibrosis. The liver may be hypoechogenic on ultrasound examination and suggest the diagnosis of nonalcoholic fatty liver disease, but the lipid-laden cells found on liver biopsy are not hepatocytes, but rather stellate cells (formerly known as Ito cells or hepatic lipocytes) which contain excess vitamin A. Chronic, moderately high doses of vitamin A (generally over 1 to 8 years) can lead to portal hypertension with ascites and esophageal varices, even before frank cirrhosis can be shown to be present. While high doses of vitamin A are usually achieved by vitamin A supplements, hypervitaminosis A can also occur with excessive dietary intake of liver, particularly that of carnivores (bears, seals, dogs) or salt-water fish (cod liver oil).

Likelihood score: A[H] (well established cause of liver injury when used in high doses).

### Mechanism of Injury

Vitamin A in high doses is a direct toxin. Excess vitamin A is stored in stellate cells in the liver and accumulation can lead to their activation and hypertrophy, excess collagen production, fibrosis and liver injury. The toxicity is dose related and can be reproduced in animal models.

### Outcome and Management

The liver injury caused by high doses of vitamin A is reversible in its early stages, but may resolve only slowly with discontinuation of ingestion and resumption of a normal diet. Patients should be specifically told to avoid all vitamin supplements that contain vitamin A and to follow a low vitamin A diet. In general, patients with known chronic liver diseases should avoid ingestion of more than the minimal daily requirement of vitamin A as underlying liver disease appears to increase the susceptibility to vitamin A toxicity.

Drug Class: Vitamins

Other Drugs in the Subclass:

- Retinoids
  - Acitretin, Etretinate
  - Isotretinoin
  - Bexarotene

## CASE REPORTS

### Case 1. Hypervitaminosis A in an adult.(1)

An 18 year old woman who had been taking vitamin A for an unspecified skin disorder in a dose of 100,000 to 200,000 IU daily for approximately 16 months developed muscular stiffness and fatigue which was particularly worsened by exercise. She subsequently noted bone pain, headache, poor appetite, nosebleeds, dry skin and generalized pruritus. She denied jaundice. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Physical examination showed dry scaly skin, cheilosis, and enlargement of the liver and spleen. Laboratory tests showed normal serum bilirubin, but AST 80 U/L and alkaline phosphatase of 129 U/L. Serum vitamin A levels were markedly elevated (737 µg/dL [normal 37-45]). All supplementary vitamin A was stopped and her symptoms improved markedly within the next 2 months. However, she continued to have hepatomegaly, mildly elevated serum enzymes and prolongation of prothrombin time (25 seconds) and decrease in serum albumin (3.4 g/dL). Ten months after stopping vitamin A, she still complained of fatigue and nosebleeds. There were mild elevations in serum bilirubin (2.5 mg/dL) and prothrombin time (21 seconds). A liver biopsy showed cirrhosis and fatty change in both hepatocytes and sinusoidal cells, fluorescence microscopy demonstrating vitamin A.

#### Key Points

Medication: | Vitamin A (100,000-200,000 IU daily)
Pattern: | Minimal serum enzyme elevations
Severity: | 4+ (cirrhosis)
Latency: | 18 months
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Vitamin A (µg/dL) | Other
19 months | 0 | 80 | 129 | 737 | Vitamin A stopped
21 months | 2 months | 55 | 105 | 155
23 months | 4 months | 49 | 117
27 months | 8 months | 53 | 129 | 97.2
29 months | 10 months | 50 | 94 | | Liver biopsy: cirrhosis
35 months | 16 months | 53 | 71 | 92.1
Normal Values | | <40 | <115 | <45

#### Comment

The typical manifestations of vitamin A toxicity are dry skin, cheilosis, dermatitis, joint and bone pain, headaches, and fatigue. A high proportion of patients also have liver test abnormalities, but these are typically mild. Jaundice is uncommon, but enlargement of the liver may be present. The presence of splenomegaly suggests that cirrhosis or portal hypertension was present at the time of initial presentation, as vitamin A is not stored in the spleen and does not cause splenomegaly on its own. The persistence of liver test abnormalities and coagulopathy eventually led to a liver biopsy that showed incomplete cirrhosis. By that time, serum vitamin A levels had fallen (although still elevated) and stellate cell hypertrophy was not prominent.

### Case 2. Hypervitaminosis A and cirrhosis in an adult.(2)(3)

A 63 man who had been taking 400,000 IU of vitamin A daily for 8 years developed dry and fissured skin followed by general fatigue and abdominal swelling. He had no history of liver disease, jaundice or alcohol abuse. He had been treated for tuberculosis 3 years previously. He took no other medications; the vitamin A was taken under the belief that it would help prevent upper respiratory tract infections. On physical examination, he was not jaundiced, but had spider nevi, mild ascites and hepatosplenomegaly. Laboratory tests showed minimal elevations in liver tests with serum bilirubin of 1.2 mg/dL, ALT 30 U/L, AST 34 U/L, and alkaline phosphatase 45 U/L. The platelet count was 110,000/µL, albumin 3.0 g/dL and vitamin A level 84.6 µg/dL (normal 30-50). Barium swallow showed esophageal varices, and a liver biopsy revealed marked enlargement of perisinusoidal stellate cells with fat droplets and positive vitamin A fluorescence. There was sinusoidal congestion and an increase in fibrosis without frank cirrhosis. Vitamin A was discontinued, but he showed little improvement when seen 8 months later (Table). Four years after initial presentation, he was admitted to another hospital for worsening ascites. Laboratory testing showed similar liver test abnormalities, although serum albumin had fallen to 2.6 g/dL. A liver biopsy showed marked cirrhosis and presence of multiple hypertrophied stellate cells with characteristic vitamin A fluorescence. The patient was no longer taking high dose vitamin A, but was on a daily multivitamin (with 10,000 IU of vitamin A) and followed a diet that was high in vitamin A (rich in liver and carrot juice, which was calculated to be more than 50,000 IU daily).

#### Key Points

Medication: | Vitamin A (400,000 IU daily, later 60,000 IU daily)
Pattern: | Minimal serum enzyme elevations
Severity: | 4+ (cirrhosis)
Latency: | 8 years
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Vitamin A (µg/dL) | Other
8 years | 0 | 34 | 35 | 1.2 | 84.6 | Vitamin A stopped
9 years | 8 months | 49 | | 1.4 | 82
12 years | 4 years | 60 | 205 | 2.3
Normal Values | | <34 | <45 | <1.2 | <50

#### Comment

While signs of portal hypertension were present initially, liver biopsy histology suggested that there was fibrosis without cirrhosis. The portal hypertension (ascites, varices) was attributed to sinusoidal encroachment due to hypertrophy of perisinusoidal stellate cells. Another publication on this same patient described clinical progression and a follow up liver biopsy showing unequivocal cirrhosis. Interestingly, the patient was convinced that vitamin A was important for health and had increased his dietary intake of vitamin A from natural sources, resulting in persistence of vitamin A hepatotoxicity. Hypervitaminosis A and liver disease have been described from excessive dietary intake without supplementation, but this outcome generally requires extraordinary intake from natural sources of the vitamin such as with carrot juice and daily ingestion of liver. Patients with hypervitaminosis A should be instructed to discontinue all supplementation and to avoid foods with high vitamin A content.

### Case 3. Acute liver injury due to hypervitaminosis A.(4)

A 31 year old woman with psoriasis was treated with high doses of vitamin A (3.5 million IU daily) for 3 weeks. During the third week of therapy, she developed fatigue, severe headaches, loss of appetite, weight loss, nausea and vomiting, thirst and pains in both legs. After the fourth week, she developed jaundice and was admitted for evaluation. On examination, her skin was dry and scaly, but the psoriatic lesions had mostly healed. She was clinically jaundiced and had hepatomegaly. Laboratory tests showed total bilirubin of 8.1 mg/dL, ALT 11 U/L and alkaline phosphatase 110 U/L. Over the following week, she developed a severe hemolytic anemia with hemoglobin falling from 12.5 to 5.0 g/dL, which was treated with blood transfusions and high doses of methylprednisolone. A liver biopsy showed enlargement of stellate cells with fat droplets and intrahepatic cholestasis. She developed almost total alopecia a few days after stopping vitamin A supplementation, but then began to improve. Two months later, she was asymptomatic of liver disease and all laboratory tests were normal, although her psoriasis was worse.

#### Key Points

Medication: | Vitamin A (3,500,000 IU daily)
Pattern: | Minimal serum enzyme elevations
Severity: | 4+ (cirrhosis)
Latency: | 4 weeks
Recovery: | Complete in 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 weeks | 0 | 11 | 130 | 8.1 | Admission
| 3 days | 14 | 130 | 7.4 | (Direct=3.7)
5 weeks | 1 week | 17 | 110 | 3.0
7 weeks | 3 week | 9 | 120 | 3.2
3 months | 2 months | 6 | 75 | 0.5
Normal Values | | <12 | <130 | <1.2

#### Comment

Acute hypervitaminosis A is usually marked by severe headaches, nausea, vomiting and bone pain and can be associated with acute hepatic injury which resolves rapidly on stopping excess vitamin A intake.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vitamin A – Generic, Aquasol A®

DRUG CLASS

Vitamins (Vitamin A)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vitamin%20A)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Vitamin A (as Retinol) | 68-26-8 | C20-H30-O

## CITED REFERENCES

1 Muenter MD, Perry HO, Ludwig J. (1971). Chronic vitamin A intoxication in adults. Hepatic, neurologic and dermatologic complications. Am J Med.
2 Russell RM, Boyer JL, Bagheri SA, Hruban Z. (1974). Hepatic injury from chronic hypervitaminosis A resulting in portal hypertension and ascites. N Engl J Med.
3 Jacques EA, Buschmann RJ, Layden TJ. (1979). The histopathologic progression of vitamin A-induced hepatic injury. Gastroenterology.
4 Leicht E, Strunz J, von Seebach HB, Meiser RJ, Mäusle E. (1973). Med Klin.

## ANNOTATED BIBLIOGRAPHY

References updated: 04 November 2020

Zimmerman HJ. Vitamin A (retinol). Drugs used in dermatotherapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 727-9. (Expert review of hepatotoxicity of vitamin A and the retinoids published in 1999).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements).
Henderer JD, Rapuano CJ. Ocular pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1251-70. (Textbook of pharmacology and therapeutics).
Popper H. (1941). Histologic distribution of vitamin A in human organs under normal and pathological conditions. Arch Path. (Analysis of histological distribution of vitamin A using fluorescence microscopy; fluorescence is not a general property of lipids and identifies vitamin A which in liver is in nonparenchymal cells, interpreted as being macrophages, despite absence of vitamin A fluorescence in the spleen).
Popper H, Steigmann F, Zevin S. (1943). On the variations of the plasma vitamin A level after the administration of large doses of vitamin A in liver disease. J Clin Invest. (Serum levels of vitamin A were measured in 108 subjects given known amounts, low levels of vitamin A and poor absorption found in patients with obstructive liver disease and hepatitis with jaundice).
Rodahl K, Moore T. (1943). The vitamin A content and toxicity of bear and seal liver. Biochem J. (Specimens of polar bear and seal liver from Greenland expeditions were tested for vitamin A levels and found to have 12-26,000 IU per gram, suggesting hypervitaminosis A as the cause of illness after eating bear liver; tests of toxicity in rats "were difficult because of the reluctance of the rats to eat the liver").
Josephs HW. (1944). Hypervitaminosis A and carotenemia. Am J Dis Child. (Initial case report of hypervitaminosis A; a 3 year old boy on high doses of vitamin A [daily cod liver oil] developed anorexia followed by listlessness, bone pain, hyperostosis on X-ray, alopecia, hepatosplenomegaly and anemia [vitamin A 910 IU/dL, bilirubin 1.6 mg/dL, Alk P 1.5 times ULN], and improved on stopping cod liver oil supplements).
Sulzberger MB, Lazar MP. (1951). Hypervitaminosis A: report of a case in an adult. J Am Med Assoc. (Initial report in adults: 44 year old woman taking 600,000 IU of vitamin A daily for 18 months presented with alopecia, amenorrhea, bone pains, and cheilosis; no discussion of liver injury).
Reyersbach GC, Hanelin J, Joplin RJ. (1952). Vitamin A intoxication: report of a case. N Engl J Med. (3 year old girl developed bone pain, alopecia and irritability after receiving 240,000 IU of vitamin A daily for 1 year, hyperostosis on bone films, improving one year later; no mention of liver abnormalities).
Bifulco E. (1953). Vitamin A intoxication: report of a case in an adult. N Engl J Med. (52 year old woman on vitamin A [100,000 IU/day] for 4 years developed fatigue, alopecia, joint pains, exophthalmos, and bleeding tendency, improving on stopping vitamin A; no mention of liver abnormalities).
Gerber A, Raab AP, Sobel AE. (1954). Vitamin A poisoning in adults: with description of a case. Am J Med. (Extensive review of the history of vitamin A toxicity and case report; 28 year old woman with multiple admissions over 8 years with unexplained headaches, vertigo, neurological changes, nausea, muscle pains and hepatomegaly, eventually found to have high serum vitamin A levels [due to chronic doses of 500,000 IU vitamin A daily for ichthyosis], improving within 3 months of stopping).
Shaw EW, Niccoli JT. (1953). Hypervitaminosis A: report of a case in an adult male. Ann Intern Med. (25 year old man taking ~350,000 IU of vitamin A daily for two months presented with fatigue, skin rash, desquamation, alopecia and hepatomegaly [bilirubin 1.6 mg/dL, Alk P 1.5 times ULN], with rapid improvement on stopping vitamins).
Elliott RA, Dryer RL. (1956). Hypervitaminosis A: report of a case in an adult. J Am Med Assoc. (21 year old woman had fatigue and hepatomegaly [bilirubin 0.8 mg/dL, Alk P normal] after taking high doses of vitamin A [~200,000 IU daily] for 5 months for acne, improving within a month of stopping).
Oliver TK. (1958). Chronic vitamin A intoxication: report of a case in an older child and review of the literature. AMA J Dis Child. (14 year old girl developed leg pain, skin rash, desquamation and alopecia after taking 200,000 IU of vitamin A daily for 10 months for acne; literature review identified 27 cases of chronic hypervitaminosis A in children and 6 in adults).
Soler-Bechara J, Soscia JL. (1963). Chronic hypervitaminosis A: report of a case in an adult. Arch Intern Med. (39 year old woman developed fatigue, joint pains, alopecia and peripheral edema having taken excess vitamin A [75,000-150,000 IU daily] for 8 years [bilirubin 1.7 mg/dL, ALT normal, Alk P ~4 times ULN and normal liver biopsy], symptoms improving within weeks of stopping).
Bergen SS, Roels OA. (1965). Hypervitaminosis A: report of a case. Am J Clin Nutr. (62 year old woman with chronic stasis ulcers, chronic musculoskeletal pains, alopecia and dry skin found to be taking high doses of vitamin A for years, normal liver tests; improving within 2 months of stopping).
Di Benedetto RJ. (1967). Chronic hypervitaminosis A in an adult. JAMA. (51 year old woman taking ~600,000 IU of vitamin A daily for at least 3 years presented with joint pains, alopecia, dry skin and hepatomegaly [ALT, and bilirubin normal], resolving within 1-2 months of stopping).
Lane BP. (1968). Hepatic microanatomy in hypervitaminosis in man and rat. Am J Path. (24 year old man who had been taking 50,000-5,000,000 IU of vitamin A daily for 5 years had normal ALT and bilirubin, but mildly elevated Alk P, and underwent liver biopsy which showed fat droplets in "Kupffer cells" which were fluorescent, whereas hepatocytes were largely normal; similar findings were reproduced in rats given vitamin A).
Rubin E, Florman AL, Degnan T, Diaz J. (1970). Hepatic injury in chronic hypervitaminosis A. Am J Dis Child. (6 year old girl on daily doses of vitamin A developed jaundice and hepatosplenomegaly [bilirubin 6.6 mg/dL, AST 120-160 U/L], liver biopsy showing lipid and vitamin A-laden stellate cells).
Muenter MD, Perry HO, Ludwig J. (1971). Chronic vitamin A intoxication in adults. Hepatic, neurologic and dermatologic complications. Am J Med. (Two patients, 18 and 53 year old women on 100,000-400,000 IU of vitamin A daily for 1.5 months and 8 years developed bone pains, dry skin and nausea, nose bleeds and headache [bilirubin normal, AST 80, Alk P ~1.5 times ULN], both had cirrhosis: Case 1).
Katz CM, Tzagournis M. (1972). Chronic adult hypervitaminosis A with hypercalcemia. Metabolism. (18 year old man with weakness and nausea having taken 200,000 IU of vitamin A daily for acne for two years and was found to have hypercalcemia [normal ALT, Alk P 2 times ULN], was treated with iv saline and calcium fell, but he developed ascites, resolving with diuretics, liver biopsy being interpreted as normal).
Leicht E, Strunz J, von Seebach HB, Meiser RJ, Mäle E. (1973). Med Klin. (31 year old woman with psoriasis developed headache, nausea and jaundice 3 weeks after starting high doses [3.5 million units daily] of vitamin A [bilirubin 8.1 mg/dL, ALT 1-2 times ULN, Alk P 1-2 times ULN], accompanied by hemolytic anemia and alopecia, slowly resolving on stopping: Case 3).
Frame B, Jackson CE, Reynolds WA, Umphrey JE. (1974). Hypercalcemia and skeletal effects in chronic hypervitaminosis A. Ann Intern Med. (Three males, ages 7, 16 and 46 years, with hypervitaminosis A with hypercalcemia [12-14 mg/dL], Alk P elevations [~3 times ULN] and periosteal calcifications, all resolving on stopping vitamin A [only minor excess vitamin D intake]).
Muenter MD, Hypervitaminosis A. (1974). Ann Intern Med. (Editorial in response to Frame [1974] mentioning that acute vitamin A toxicity was first described by Kane, the American Arctic explorer, who in 1856 described the syndrome after members of the team ate polar bear liver; editorial argues in favor of an FDA restriction in amount of vitamin A in over-the-counter preparations).
Russell RM, Boyer JL, Bagheri SA, Hruban Z. (1974). Hepatic injury from chronic hypervitaminosis A resulting in portal hypertension and ascites. N Engl J Med. (54 and 63 year old women developed fatigue and weakness 5 and 8 years after starting high doses vitamin A [100,000 to 1.2 million IU/day], with cheilosis, alopecia, hepatosplenomegaly and ascites [bilirubin 2.2 and 1.2 mg/dL, ALT 16 and 30 U/L, Alk P 125 and 45 U/L, prothrombin time normal], biopsies showing stellate cells with fat, increased fibrosis, slow and incomplete improvement over the year after stopping: Case 2).
Kent G, Gay S, Inouye T, Bahu R, Minick OT, Popper H. (1976). Vitamin A-containing lipocytes and formation of type III collagen in liver injury. Proc Natl Acad Sci USA. (Administration of vitamin A to rats resulted in increase in "lipocytes" and type III collagen, suggesting the stellate cell is the predecessor of fibroblasts and accounts for fibrosis in the liver).
Smith FR, Goodman DS. (1976). Vitamin A transport in human vitamin A toxicity. N Engl J Med. (3 patients with hypervitaminosis A with hepatomegaly, but normal liver tests had serial determinations of vitamin A, retinol, retinyl esters and retinol binding protein [RBP] during recovery; toxicity was associated with a high molar ratio of vitamin A to RBP, suggesting that excess free vitamin A is responsible for toxicity).
Farrell GC, Bhathal PS, Powell LW. (1977). Abnormal liver function in chronic hypervitaminosis A. Am J Dig Dis. (57 year old woman developed joint pains, alopecia, dry skin, and abnormal liver tests after taking high doses of vitamin A [~90,000 IU/day] for 3-4 years [bilirubin 0.6 mg/dL, AST 72 U/L, Alk P 108 U/L], biopsy showing hypertrophied stellate cells and vitamin A fluorescence).
Kistler HJ, Pluer S, Dickenmann W, Pirozynski W. (1977). Schweiz Med Wschr. (35 year old man developed weakness, alopecia, bone pain and ascites having taken 700,000 IU of vitamin A daily for 13 months [bilirubin 1.7 mg/dL, ALT 12 U/L, Alk P 1.5 times ULN], elevated portal pressure [40 mm Hg], but biopsy showing only mild sinusoidal fibrosis without cirrhosis; withdrawal was followed by resolution of symptoms and ascites).
Fleischmann R, Schlote W, Schomerus H, Wolburg H, Castrillon-Oberndorfter WL, Hoensch H. (1977). Dtsch Med Wochenschr. (36 year old man with psoriasis was treated with high doses of vitamin A [~1 million IU daily] for seven weeks, developing vitamin A toxicity and slowly recovering, but 3 years later was found to have esophageal varices [bilirubin 1.3 mg/dL, ALT and Alk P normal, platelets 100,000/μL] with cirrhosis, ascites and splenomegaly, biopsy showing vitamin A in hypertrophied stellate cells).
Babb RR, Kieraldo JH. (1978). Cirrhosis due to hypervitaminosis A. West J Med. (72 year old man presented with ascites having taken 40,000 IU of vitamin A daily for 7 years [bilirubin 1.4 mg/dL, AST 80 U/L, Alk P 150 U/L, albumin 3.1 g/dL, prothrombin index 40%], ascites resolving 4 months after stopping vitamin A; although the liver did not show cirrhosis, he ultimately required porto-caval shunt for recurrent variceal hemorrhage).
Ferrando R, Truhaut R. (1979). Med Chir Dig.
Jacques EA, Buschmann RJ, Layden TJ. (1979). The histopathologic progression of vitamin A-induced hepatic injury. Gastroenterology. (Follow up of patient 2 described by Russell [1974] who stopped high doses of vitamin A, but continued excess ingestion by eating large amounts of carrots and liver; 3 years later he presented with worsening ascites [bilirubin 2.3 mg/dL, ALT 29 U/L, Alk P 205 U/L], liver biopsy showing cirrhosis and fat-laden stellate cells: Case 2).
Tholen W, Paquet KJ, Rohner HG, Albrecht M. (1980). Leber Magen Darm. (21 year old woman with congenital ichthyosis developed jaundice and hepatosplenomegaly after taking high doses of vitamin A for 3 years [bilirubin 3.0 mg/dL, ALT 6 U/L, Alk P 146 U/L, platelets 68,000/μL], with cirrhosis on liver biopsy and death from recurrent variceal hemorrhage 4 years later).
Mahoney CP, Margolis MT, Knauss TA, Labbe RF. (1980). Chronic vitamin A intoxication in infants fed chicken liver. Pediatrics. (Twin 7 month olds developed irritability, vomiting and bulging fontanelles 4 months after starting a diet of chicken livers [~120 g daily], with normal ALT, Alk P and bilirubin, resolving with stopping diet [estimated 40,000 IU or 12,000 μg daily]).
Lippe B, Hensen L, Mendoza G, Finerman M, Welch M. (1981). Chronic vitamin A intoxication. A multisystem disease that could reach epidemic proportions. Am J Dis Child. (Two children, ages 2 and 4, developed rash, headache, bone pain and irritability and were found to have hypercalcemia [11.3 and 15.1 mg/dL] and taking excess vitamin A, resolving on stopping; liver tests normal).
Hatoff DE, Gertler SL, Miyai K, Parker BA, Weiss JB. (1982). Hypervitaminosis A unmasked by acute viral hepatitis. Gastroenterology. (42 year old man on long term vitamin A [25,000 IU daily] and vitamin A enriched diet developed desquamation, headache, alopecia and confusion 3 weeks after onset of acute hepatitis B, biopsy showing stellate cell hypertrophy, acute onset of toxicity being interpreted as due to decreased retinoid binding protein caused by hepatitis).
Weber FL, Mitchell GE, Powell DE, Reiser BJ, Banwell JG. (1982). Reversible hepatotoxicity associated with hepatic vitamin A accumulation in a protein-deficient patient. Gastroenterology. (63 year old man presented with edema and abnormal liver tests having taken high doses of vitamin A [40-50,000 IU daily] for 7 years [bilirubin 2.7 mg/dL, ALT 313 U/L, Alk P 1075 U/L], but had low serum vitamin A levels despite high levels in liver, resolving in 6 weeks on a normal diet).
Farris WA, Erdman JW. (1982). Protracted hypervitaminosis A following long-term, low-level intake. JAMA. (16 year old boy presented with headaches, nausea and papilledema having taken 50,000 IU of vitamin A daily for 2.5 years for acne [ALT and Alk P normal], resolving in 2 months of stopping).
Rosenberg HK, Berezin S, Heyman S, Witzleben C, Watkins JB. (1982). Pleural effusion and ascites: unusual presenting features in a pediatric patient with vitamin A intoxication. Clin Pediatr (Phila). (9 year old girl developed lethargy, pleural effusion and ascites [ALT and Alk P normal] after taking 300,000 IU of vitamin A daily for at least 1 year, with resolution on stopping, liver biopsy showed minimal fibrosis and mild fat some in sinusoidal cells).
Geubel AP, Rahier J. (1983). Rev Med Liege.
Guarascio P, Portmann B, Visco G, Williams R. (1983). Liver damage with reversible portal hypertension from vitamin A intoxication: demonstration of Ito cells. J Clin Pathol. (35 year old woman developed cheilosis and ascites having taken high doses of vitamin A [90-300,000 IU daily] for 2 years [normal bilirubin and ALT], ascites resolving after 2 months of a normal diet, biopsy not showing cirrhosis, but stellate cells encroaching on sinusoids).
Olson JA. (1983). Adverse effects of large doses of vitamin A and retinoids. Semin Oncol. (Review of retinoids and vitamin A which do not share same toxicity but usually have a low therapeutic-toxic index).
Podell RN. (1983). Vitamin A supplementation. Subclinical overdose "unmasked" by hepatitis. Postgrad Med. (Review of vitamin A toxicity and the clinical report of Hatoff [1982]).
Bernstein RE. (1984). Liver and hypervitaminosis A. N Engl J Med. (Letter describing history of vitamin A toxicity caused by eating liver; particular polar bear and dog liver, but cases also described with chicken liver).
Le Marchand P, Benatre A, Metman EH, Couë C, Arbeille-Brassart B, Monegier du Sorbier C, Danquechin-Dorval E, et al. (1984). Gastroenterol Clin Biol. (75 year old woman with psoriasis on vitamin A [250,000 IU daily] for 12 years developed jaundice and cirrhosis [bilirubin 2.0 mg/dL, ALT 46 U/L, Alk P 201 U/L, platelets 133,000/μL], biopsy showing cirrhosis; patient subsequently had variceal hemorrhage).
Verneau A, Rosenbaum J, Zafrani ES, Roudot-Thoraval F, Leclercq M, Dhumeaux D. (1984). Gastroenterol Clin Biol. (36 year old man presented with ascites having taking vitamin A [200,000 IU daily] for psoriasis for 10 years [bilirubin 1.2 mg/dL, ALT 13 U/L, Alk P 33 U/L, albumin 2.8 g/dL and platelets 70,000/uL], liver biopsy showing sinusoidal fibrosis and nodularity).
Zafrani ES, Bernuau D, Feldmann G. (1984). Peliosis-like ultrastructural changes of the hepatic sinusoids in human chronic hypervitaminosis A: report of three cases. Hum Pathol. (Three patients [2 women and 1 man, ages 25 to 51 years] with hypervitaminosis A after 1-12 years of excessive intake had portal hypertension [venous gradients 14 to 17 mm Hg], biopsies showing abnormal sinusoids, swelling of perisinusoidal space and thickening of endothelial cells).
Yamamoto M. (1985). Nippon Rinsho.
Baglin A, Hagege C, Franc B, Richaud M, Prinseau J. (1986). Ann Med Interne (Paris).
Inkeles SB, Connor WE, Illingworth DR. (1986). Hepatic and dermatologic manifestations of chronic hypervitaminosis A in adults. Report of two cases. Am J Med. (29 year old man and 41 year old woman developed hypervitaminosis A on a beef liver diet for 8-9 years and high dose vitamin A pulses for 1 year, one with cirrhosis and one with abnormal liver tests [bilirubin normal, ALT 393 and 40 U/L, Alk P 120-121 U/L], improving on stopping excess vitamin A).
Witzleben CL. (1986). Case 5. Vitamin A hepatotoxicity. Pediatr Pathol.
Yob EH, Pochi PE. (1987). Side effects and long-term toxicity of synthetic retinoids. Arch Dermatol. (Retinoids are modifications of vitamin A molecule and do not share toxicities necessarily, most are not stored in the liver; hepatotoxicity of retinoids is different from that of vitamin A, usually arising within first 1-2 months and having features of hypersensitivity).
Bioulac-Sage P, Quinton A, Saric J, Grimaud JA, Mourey MS, Balabaud C. (1988). Chance discovery of hepatic fibrosis in patient with asymptomatic hypervitaminosis A. Arch Pathol Lab Med. (50 year old woman with peptic ulcer disease underwent gastric surgery and had liver biopsy that showed stellate cell hypertrophy and sinusoidal fibrosis despite normal ALT, Alk P and bilirubin; had been on high doses of vitamin A for 4 years).
Minuk GY, Kelly JK, Hwang WS. (1988). Vitamin A hepatotoxicity in multiple family members. Hepatology. (3 of 5 family members [father, mother and son] who were taking 20,000-45,000 IU of vitamin A daily for 7-10 years developed nausea and weakness and were found to have liver test abnormalities [bilirubin 0.3-1.0 mg/dL, ALT 71-265 U/L, Alk P 76-258 U/L], resolving in 6-12 months on normal diet).
Mendoza FS, Johnson F, Kerner JA, Tune BM, Shochat SJ. (1988). Vitamin A intoxication presenting with ascites and a normal vitamin A level. West J Med. (3 year old girl on 50,000 IU of vitamin A daily for 6 months presented with leg pain, irritability and skin rash and developed ascites and respiratory distress [ALT 31 U/L, Alk P 153 U/L, albumin 3.4 g/dL], liver biopsy showing central fibrosis and stellate cell hypertrophy, resolving in 4-5 months).
Smith JW. (1989). Vitamin A toxicity presenting as jaundice. Postgrad Med.
Baker H, ten Hove W, Kanagasundaram N, Zaki G, Leevy CB, Frank O, Leevy CM. (1990). Excess vitamin A injures the liver. J Am Coll Nutr. (56 year old woman developed fatigue, weakness, alopecia, bone pain and ascites after taking vitamin A [~60,000 IU daily] for 12 years [bilirubin 3.2 mg/dL, AST 313 U/L, Alk P 1075 U/L], hepatic venous pressure gradient was 19 mm Hg and liver biopsy showed stellate cell hypertrophy, sinusoid fibrosis but not frank cirrhosis, most abnormalities resolved 6 months after stopping excess intake).
Belaiche J, Gast P, Lambinet N, Etienne M, Fridman V, Vivario M, Boniver J. (1990). Rev Med Liege.
Sarles J, Scheiner C, Sarran M, Giraud F. (1990). Hepatic hypervitaminosis A: a familial observation. J Pediatr Gastroenterol Nutr. (4 siblings with congenital ichthyosis taking high doses of vitamin A developed liver disease [bilirubin 0.4-1.4 mg/dL, ALT 13-54 U/L, Alk P 184-1069 U/L]; biopsies showed stellate cell hypertrophy and variable degrees of fibrosis).
Fallon MB, Boyer JL. (1990). Hepatic toxicity of vitamin A and synthetic retinoids. J Gastroenterol Hepatol. (Review of liver injury due to vitamin A and retinoids identified 18 case reports of vitamin A hepatotoxicity in the English literature, patients ages 6 to 63 years, presenting with rash, fatigue, hepatomegaly and hepatic synthetic dysfunction, biopsy showing fat in stellate cells and fibrosis; in contrast, there is little evidence that isotretinoin causes liver injury other than mild rapidly reversible ALT elevations; etretinate causes ALT elevations in ~20% of patients and case reports of clinically apparent injury have been published, but vary in clinical patterns).
Geubel AP, De Galocsy C, Alves N, Rahier J, Dive C. (1991). Liver damage caused by therapeutic vitamin A administration: estimate of dose-related toxicity in 41 cases. Gastroenterology. (Retrospective analysis of 41 cases of hypervitaminosis A with liver injury seen between 1976 and 1989 at one institution, diagnosis often delayed [0-10 years], intake of 20,000-400,000 IU daily for 0.2 to 15 years, those with cirrhosis [n=17] having taken more and for a longer time; 6 died of liver disease and two underwent liver transplantation).
Anonymous. (1991). Iatrogenic liver disease from vitamin A. Nutr Rev. (Editorial on dangers of vitamin A therapy of dermatologic diseases based on study of Geubel [1991]).
Burillo Lorente J, Castellote Alonso J, Massanes Bohigas PR. (1991). Rev Clin Esp.
Dubois A, Balducchi JP, Barbuat C, Fabre J, Flaisler F, Joujoux JM, Pignodel C, et al. (1991). Rev Med Interne. (Two women, 39 and 43 years old, presented with ascites and liver biopsy showing stellate cell hypertrophy, one having taken methoxypsoralen [for tanning] and one Plethoryl [which contains a synthetic retinoid for weight loss] for several years, improving on stopping).
Oren R, Ilan Y. (1992). Reversible hepatic injury induced by long-term vitamin A ingestion. Am J Med. (56 year old woman taking 5000 IU of vitamin A daily developed nausea and abdominal pain [bilirubin normal, ALT 151 U/L, Alk P 870 U/L], liver biopsy showing portal fibrosis [no mention of stellate cell morphology], liver tests improving upon stopping and worsening again upon restarting the "normal doses" of vitamin A).
Scoazec JY, Bouma ME, Roche JF, Blache D, Verthier N, Feldmann G, Gay G. (1992). Liver fibrosis in a patient with familial homozygous hypobetalipoproteinaemia: possible role of vitamin supplementation. Gut. (21 year old woman with abetalipoproteinemia and fatty liver was treated with vitamin A [15,000 IU daily] and found to have elevations in ALT [2 times ULN] 2 years later, repeat liver biopsy showing fibrosis and worsening steatosis, but normal stellate cells).
Theiler R, Wirth HP, Flury R, Hanck A, Michel BA. (1993). Schweiz Med Wochenschr.
Kowalski TE, Falestiny M, Furth E, Malet PF. (1994). Vitamin A hepatotoxicity: a cautionary note regarding 25,000 IU supplements. Am J Med. (45 year old woman developed fatigue, pruritus, jaundice and hepatomegaly having taken vitamin A in an over-the-counter preparation of 25,000 IU daily for 6 years [bilirubin 6.3 mg/dL, ALT 67 U/L, Alk P 585 U/L], biopsy showing severe fibrosis, cholestasis and stellate cell hypertrophy; her condition gradually worsened despite stopping and she died 10 weeks later).
Horsmans Y, Rahier J, Geubel AP. (1995). Hepatic injury and vitamin A ingestion. Am J Med. (Letter in response to Oren [1992] pointing out the unusual clinical features of the case described).
Croquet V, Pilette C, Lespine A, Vuillemin E, Rousselet MC, Oberti F, Saint André P, et al. (2000). Hepatic hyper-vitaminosis A: importance of retinyl ester level determination. Eur J Gastroenterol Hepatol. (32 year old man with history of leukemia and bone marrow transplantation, taking 50,000 IU of vitamin A daily for 15 years presented with variceal hemorrhage, liver biopsy showing stellate cell hypertrophy but no fibrosis [ALT 54 U/L, Alk P 117], vitamin A was stopped but he continued to have liver test abnormalities and presented with ascites 5 years later, biopsy again showing minimal fibrosis).
Mawson AR, Steele TA. (2001). Possible role of retinoids in hepatitis B virus-associated liver damage. Exp Biol Med (Maywood). (Review and hypothesis regarding interactions of vitamin A, retinoids and hepatitis B virus infection).
Miksad R, de Lénghen V, McDougall C, Fiel I, Rosenberg H. (2002). Hepatic hydrothorax associated with vitamin A toxicity. J Clin Gastroenterol. (52 year old woman presented with ascites and dyspnea having taken high doses of vitamin A for 18 years [bilirubin not given, ALT 45 U/L, Alk P 160 U/L], with hydrothorax, liver biopsy showing stellate cell hypertrophy and pericellular fibrosis; hepatic venous pressure gradient was 10 mm Hg; gradual but incomplete improvement on stopping vitamin A).
Bahcecioglu IH, Yalniz M, Ilhan N, Ataseven H, Ozercan IH. (2005). Levels of serum vitamin A, alpha-tocopherol and malondialdehyde in patients with non-alcoholic steatohepatitis: relationship with histopathologic severity. Int J Clin Pract. (Vitamin A levels were higher in 29 patients with nonalcoholic steatohepatitis than in 10 controls [2.1 vs 1.4 μmol/L], whereas vitamin E levels tended to be lower [42.8 vs 47.5 μmol/L]; no correlation with degree of ALT elevations).
Nollevaux MC, Guiot Y, Horsmans Y, Leclercq I, Rahier J, Geubel AP, Sempoux C. (2006). Hypervitaminosis A-induced liver fibrosis: stellate cell activation and daily dose consumption. Liver Int. (Reanalysis of liver biopsy material from 9 of the 41 patients described by Geubel [1991] showed correlation between amount of fibrosis and number of activated stellate cells and perisinusoidal fibrosis and estimated daily consumption of vitamin A).
Castaño G, Etchart C, Sookoian S. (2006). Vitamin A toxicity in a physical culturist patient: a case report and review of the literature. Ann Hepatol. (25 year old man taking 220,000 IU of vitamin A daily developed abnormal liver tests [ALT 104 U/L, Alk P 361 U/L, GGT 392 U/L], biopsy showing hypertrophied stellate cells and advanced fibrosis).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004-2008, one was attributed to acitretin, but none to vitamin A).
Ramanathan VS, Hensley G, French S, Eysselein V, Chung D, Reicher S, Pham B. (2010). Hypervitaminosis A inducing intra-hepatic cholestasis - a rare case report. Exp Mol Pathol. (46 year old man developed jaundice having taken multivitamins and a vitamin A containing Herbalife product for 12 years [bilirubin 11.2 mg/dL, ALT 58 U/L, Alk P 193 U/L]; ERCP showed a biliary stricture, but there was little improvement after sphincterotomy and a liver biopsy showed cholestasis and lipid filled stellate cells, abnormalities resolving with stopping vitamin A product).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, isotretinoin was the most frequently mentioned agent [420 cases: 6.4%], but no information on the characteristics of the cases was provided).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, no cases were attributed to vitamin A or retinoids).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamin A or a retinoid).
Mas Morey P, Nigorra Caro M, Cladera Serra A, Nicolás Picó J. (2011). Possible fulminant toxicity by all-trans-retinoic acid in a patient with acute promyelocytic leukemia. Farm Hosp. (33 year old woman with promyelocytic leukemia treated with all-trans-retinoic acid developed acute liver failure within 3 weeks of starting [bilirubin 1.1 rising to 17.4 mg/dL], with progressive pulmonary and renal failure and death 25 days later).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of the hepatotoxicity of herbals and nutritional supplements including vitamin A, toxic levels being above 50,000 IU daily, but toxic dose is lower in persons with risk factors such as underlying liver disease).
Zhang H, Zhang J, Dong H. (2018). Fatal hepatotoxicity due to viaminate. Am J Med Sci. (43 year old Chinese woman developed abdominal distension one month after starting viaminate, a tretinoin derivative [bilirubin 9.4 mg/dL, ALT 1504 U/L, Alk P 105 U/L, INR 1.47], with progressively worsening jaundice and hepatic encephalopathy, dying of hepatic failure 38 days after admission and autopsy showing massive necrosis).
Fox R, Stace N, Wood K, French C. Liver toxicity from vitamin A. JGH Open 2019; 4: 287-8. (27 year old female developed fatigue 18 months after starting vitamin A [bilirubin 0.9 mg/dL, ALT 15 U/L, Alk P 208 U/L], biopsy showing microvesicular fat and prominent stellate cells] with slow improvement after stopping vitamin A).
Kulkarni AV, Kumar P, Talukdar R, Rao NP. (2020). Steroids as rescue therapy for vitamin A-induced acute liver failure. BMJ Case Rep. (34 year old man developed jaundice having taken vitamin A [5000 IU] twice daily for 7 years [bilirubin 3.2 mg/dL, ALT 1802 U/L, Alk P 119 U/L, INR 0.96], with abnormal transient elastography and microvesicular fat and prominent stellate cells on liver biopsy; when there was no change in liver tests for 2 weeks after stopping vitamin A, prednisone was started and tests began to improve rapidly; he later tolerated discontinuation of prednisone without a subsequent relapse ).

## OTHER REFERENCE LINKS

1 Recent References on Vitamin A: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Vitamin%20A/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vitamin A: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamin%20A)